# Voxelotor

## OVERVIEW

### Introduction

Voxelotor is an oral inhibitor of hemoglobin S polymerase that is used in the therapy of sickle cell disease. Voxelotor has been associated with rare instances of mild-to-moderate serum enzyme elevations during therapy, but has not been linked to instances of idiosyncratic acute liver injury.

### Background

Voxelotor (vox el’ oh tor) is an orally available, small molecule inhibitor of hemoglobin S polymerase, an enzyme which promotes the aggregation of deoxygenated hemoglobin S. Inhibition of this enzyme decreases sickling of red blood cells. Sickle cell disease is caused by an inherited mutation in the β globin gene that creates hemoglobin S, which is prone to aggregation with deoxygenation resulting in sickling of red blood cells, hemolytic anemia, and recurrent painful crises involving different organs and tissues. Sickle cell disease affects at least 100,000 Americans and is most common in persons of African descent. Long term complications include disability due to recurrent painful crises, acute chest syndrome, pulmonary hypertension, stroke and cerebral infarcts, end-organ damage and early mortality. In clinical trials in patients with frequent sickle cell crises, voxelotor therapy was associated with a decrease in sickling, improvement in hemoglobin levels and decreases in reticulocytes and indirect bilirubin levels. Despite the apparent decrease in hemolysis, however, rates of vaso-occlusive crises were similar with voxelotor and placebo treatment. Furthermore, HbS when bound to voxelotor delivers very little oxygen and the increase in hemoglobin levels may therefore not equate with better oxygenation of tissues. Voxelotor was approved in the United States in 2019 as therapy for sickle cell disease in adults and children 12 years or older. Voxelotor is available in tablets of 500 mg under the brand name Oxbryta. The recommended dose in adults is 1,500 mg once daily. Side effects can include headache, diarrhea, abdominal pain, nausea, fatigue, rash and fever. Uncommon, but potentially serious side effects include hypersensitivity reactions.

### Hepatotoxicity

In clinical trials of voxelotor in patients with sickle cell disease, serum aminotransferase elevations occurred in 1% to 2% of patients during therapy, but the elevations were usually asymptomatic, self-limited in course and mild-to-moderate in degree. Patients with sickle cell disease frequently have liver test abnormalities and most have some degree of jaundice, due largely to hemolysis. They are also at risk for gall stone disease (from chronic hemolysis), chronic hepatitis B and C (from blood transfusions), iron overload (from frequent transfusions), congestive liver disease (due to pulmonary hypertension), and veno-occlusive crises involving the liver which can be associated with serum aminotransferase elevations. In preregistration trials of voxelotor, hepatic events were no more common with the active drug than with placebo. Rare instances of acute aminotransferase elevations of unknown cause occurred in patients receiving voxelotor, but were self-limited in course and were not associated with worsening of preexisting bilirubin elevations or need for dose modification or discontinuation.

Likelihood score: E* (unproven but possible cause of acute liver injury with jaundice).

### Mechanism of Injury

The mechanism by which voxelotor might cause liver injury is unknown, but may be due to an intermediate product of its metabolism. Voxelotor is metabolized in the liver largely by the CYP 3A4 and is susceptible to drug-drug interactions with inhibitors or inducers of this enzyme reactivity and with other CYP 3A4 substrates.

### Outcome and Management

Liver injury due to voxelotor is generally mild and asymptomatic. Elucidating the cause of liver test abnormalities in patients with sickle cell disease is difficult as they are susceptible to several forms of liver injury including acute viral hepatitis, iron overload, gallstone disease, congestive hepatopathy from pulmonary hypertension, and ischemic liver injury from hepatic sickling crises.

Drug Class: Genetic Disorder Agents, Hematologic Agents, Sickle Cell Disease Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Voxelotor – Oxbryta®

DRUG CLASS

Sickle Cell Disease Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Voxelotor)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Voxelotor | 1446321-46-5 | C19-H19-N3-O3

## ANNOTATED BIBLIOGRAPHY

References updated: 12 July 2021

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of voxelotor).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2019/213137Orig1s000Multidiscipline.pdf (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA multidisciplinary scientific review of the voxelotor application for safety and efficacy which mentions one participant in the preregistration clinical trial who developed an acute, transient, anicteric hepatitis while receiving voxelotor).
Koh C, Turner T, Zhao X, Minniti CP, Feld JJ, Simpson J, Demino M, et al. (2013). Liver stiffness increases acutely during sickle cell vaso-occlusive crisis. Am J Hematol. (Among 23 patients with sickle cell disease evaluated before and during an acute vaso-occlusive crisis, serum liver enzyme elevations did not change appreciably, but hepatic stiffness increased [measured by ultrasound transient elastography] as did serum total and indirect bilirubin and reticulocyte counts, while serum albumin and hemoglobin decreased).
Feld JJ, Kato GJ, Koh C, Shields T, Hildesheim M, Kleiner DE, Taylor JG, et al. (2015). Liver injury is associated with mortality in sickle cell disease. Aliment Pharmacol Ther. (Among 247 patients with sickle cell disease, liver disease was common, elevations in ALT were present in 16% and alkaline phosphatase in 33%; factors associated with mortality during follow up were iron indices [serum ferritin, transferrin, and iron] and liver abnormalities [direct bilirubin, albumin and alkaline phosphatase levels]; liver biopsy done in 40 patients revealed nodular regenerative hyperplasia in 36% and portal venopathy in 23%).
Blyden G, Bridges KR, Bronte L. (2018). Case series of patients with severe sickle cell disease treated with voxelotor (GBT440) by compassionate access. Am J Hematol. (Among 7 patients with sickle cell disease and frequent vaso-occlusive crises treated with voxelotor on a compassionate use basis, therapy was well tolerated and hemoglobin levels increased in most, but one patient with preexisting severe hemosiderosis had progressive hepatic failure and died).
Howard J, Hemmaway CJ, Telfer P, Layton DM, Porter J, Awogbade M, Mant T, et al. (2019). A phase 1/2 ascending dose study and open-label extension study of voxelotor in patients with sickle cell disease. Blood. (Among 38 patients with sickle cell disease receiving voxelotor [500, 700 or 1000 mg daily for 28 days or 900 mg for up to 6 months] therapy was well tolerated overall, the most common adverse events being headache, diarrhea and rash, while only 2 patients had serum enzyme elevations which were mild and transient [1-3 times ULN]).
Vichinsky E, Hoppe CC, Ataga KI, Ware RE, Nduba V, El-Beshlawy A, Hassab H, et al., HOPE Trial Investigators. (2019). A phase 3 randomized trial of voxelotor in sickle cell disease. N Engl J Med. (Among 274 patients, ages 12 to 65 years, with sickle cell disease treated with voxelotor [900 or 1500 mg] or placebo once daily for an average of 42 weeks, hemoglobin levels increased with voxelotor [by 1.1 and 0.6 g/dL vs -0.1 g/dL with placebo] and reticulocyte counts and indirect bilirubin decreased, while adverse event rates were similar in the three groups, no mention of ALT elevations or hepatotoxicity).
Blair HA. (2020). Voxelotor: first approval. Drugs. (Review and summary of the mechanism of action, history of development, pharmacology, clinical efficacy and safety of voxelotor shortly after its initial approval in the US mentions that adverse events with therapy were mostly mild and most commonly diarrhea and headache; no mention of ALT levels or hepatotoxicity).
(2020). Two drugs for sickle cell disease. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and costs of crizanlizumab and voxelotor shortly after their approval for use in sickle cell disease in the US; no mention of ALT elevations or hepatotoxicity).
Han J, Saraf SL, Gordeuk VR. (2020). Systematic review of voxelotor: a first-in-class sickle hemoglobin polymerization inhibitor for management of sickle cell disease. Pharmacotherapy. (Review of the mechanism of action, clinical efficacy and safety of voxelotor in sickle cell disease, does not mention ALT elevations or hepatotoxicity).
Darbari DS, Sheehan VA, Ballas SK. (2020). The vaso-occlusive pain crisis in sickle cell disease: definition, pathophysiology, and management. Eur J Haematol. (Extensive review of the pathogenesis of vaso-occlusive crisis in patients with sickle cell disease and therapies that target different steps in the process including inflammation, adhesion, oxidative stress and oxygen affinity and stability of hemoglobin; discusses efficacy of L-glutamine, voxelotor and crizanlizumab, mentioning that all three are well tolerated; no mention or discussion of hepatotoxicity).
Ali MA, Ahmad A, Chaudry H, Aiman W, Aamir S, Anwar MY, Khan A. (2020). Efficacy and safety of recently approved drugs for sickle cell disease: a review of clinical trials. Exp Hematol. (Review of randomized controlled trials of 3 recently approved drugs for sickle cell disease focusing upon L-glutamine, voxelotor, and crizanlizumab states that all three are “well tolerated without any alarming adverse effects”; no mention of ALT elevations or hepatotoxicity).
Tisdale JF, Thein SL, Eaton WA. (2020). Treating sickle cell anemia. Science. (Review of mechanism of action and efficacy of current [hydroxyurea and voxelotor] and the promise of future therapies of sickle cell anemia [including bone marrow transplantation and gene therapy], mentions that voxelotor binds to the high oxygen affinition, non-polymerizing R conformation of HbS, but when bound to the drug, the HbS delivers very little oxygen, so that the increase in hemoglobin concentrations with therapy may not result in better oxygenation of tissue).
Pace BS, Starlard-Davenport A, Kutlar A. (2021). Sickle cell disease: progress towards combination drug therapy. Br J Haematol. (Review of the pathophysiology of sickle cell disease and vaso-occlusive crises and mechanism of action of drugs used to treat sickle cell disease and drugs currently under investigation for efficacy in decreasing the microvascular occlusive crises that mediate much of the morbidity and mortality of this disease).
Howard J, Ataga KI, Brown RC, Achebe M, Nduba V, El-Beshlawy A, Hassab H, et al. (2021). Voxelotor in adolescents and adults with sickle cell disease (HOPE): long-term follow-up results of an international, randomised, double-blind, placebo-controlled, phase 3 trial. Lancet Haematol. (Among 247 patients with sickle cell disease treated with voxelotor [1500 or 900 mg] or placebo for up to 72 weeks, hemoglobin levels improved by 1.0 and 0.51 g/L with voxelotor vs 0.0 g/dL with placebo, while total and severe adverse event rates were similar in all groups; no mention of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Voxelotor: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Voxelotor+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Voxelotor: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Voxelotor)